# Folic Acid

## OVERVIEW

### Introduction

Folic acid is a water soluble vitamin found in many foods and particularly in leafy green vegetables that is essential for the critical biosynthetic pathways involving transfer of methyl groups to organic compounds. There is no evidence that folic acid, in physiologic or even super-physiologic, high doses, causes liver injury or jaundice.

### Background

Folic acid (fo' lik a' cid) is the critical water soluble vitamin that plays an essential role in many biosynthetic pathways largely as a major donor of one-carbon molecules such as methyl groups. Folic acid is a pteroylglutamic acid, but it exists in several related congeners such as tetrahydrofolic acid (the activated form of the vitamin) as well as methyltetrahydrofolate, methenyltetrahydrofolate, and folinic acid which have different concentrations in foods, degrees of bioavailability and levels of activity. These related molecules are collectively referred to by the generic term folate. Folate deficiency is characterized by weakness, macrocytic anemia, diarrhea, cheilosis and glossitis. Folate is found in many foods and particularly in fresh green vegetables, liver and some fruits. Grain products and cereals are fortified with folic acid, and its deficiency is now rare in the United States, found largely in patients with small bowel malabsorption syndromes, severe malnutrition or chronic alcoholism. Normal plasma folate levels in adults are 2 to 20 ng/mL (4.5 to 45 nmol/L) and red cell folate, a better indicator of chronic intake, 140 to 628 ng/mL (317-1422 nmol/L). The recommended daily allowance of folate in adults is 400 µg for both men and women, higher intakes being recommended during pregnancy and in the elderly. Folate supplements are taken by a large proportion of the American population, driven partially by the belief that higher doses of folate may improve metabolic fitness and decrease the risk of aging related conditions, such as atherosclerosis, cancer and dementia. These benefits of increased folate intake, however, have not been shown in prospective controlled trials. Folic acid is available in multiple, over-the-counter forms in concentrations of 200 to 1000 µg, and it is a component of virtually all multivitamin preparations usually at levels of 200 to 400 µg. Oral intake of more than 1000 µg daily is not recommended. Parenteral forms of folic acid are also available including leucovorin, which is an approved prescription drug used to reverse the effects of folate antagonists such as methotrexate, trimetrexate and pemetrexed. Oral forms of folic acid have few if any side effects and there are no proven adverse events associated with high doses. Injectable forms of folic acid have been implicated in rare instances of hypersensitivity reactions.

### Hepatotoxicity

Neither normal nor excessively high intakes of folate are associated with liver injury or liver test abnormalities. In long term clinical trials, serum enzyme and bilirubin elevations were no more frequent with folic acid therapy than with placebo. Use of high doses of folic acid (up to 15 mg daily) has not been associated with appreciable adverse reactions, ALT elevations or hepatotoxicity.

Likelihood score: E (unlikely cause of liver injury).

### Mechanism of Injury

It is not clear how folate might cause liver injury. Folate is stored in the liver, but it is metabolized in many tissues and has no effects on the hepatic microsomal enzyme systems.

Drug Class: Vitamins

Other Drugs in the Class: Vitamin A, Vitamin B, Vitamin C, Vitamin D, Vitamin E, Vitamin K, Niacin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Folic Acid – Generic, Combination Products (some include leucovorin)

DRUG CLASS

Vitamins

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Folic%20Acid)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Folic Acid | 59-30-3 | C19-H19-N7-O6 | Folic Acid chemical structure
Leucovorin | 58-05-9 | C20-H23-N7-O7 | Leucovorin chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 06 February 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999; does not discuss folate).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp, 631-57. (Review of hepatotoxicity of dietary supplements; does not discuss vitamins and minerals).
Kaushansky K, Kipps TJ. Hematopoietic agents: growth factors, minerals and vitamins. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1067-1100. (Textbook of pharmacology and therapeutics).
Herbert Victor. Folic acid. In, Shils ME, Olson JA, Shike M, Ross AC, eds. Modern nutrition in health and disease. 9th ed. Baltimore: Williams & Wilkins, 1998; pp 433-46. (Textbook of nutrition).
Food and Nutrition Board, Institute of Medicine. Dietary reference intakes for thiamin, riboflavin, niacin, vitamin B6, folate, vitamin B12, pantothenic acid, biotin and choline. Washington DC: National Academy Press, 1998. (Reports from the Food and Nutrition Board of the Institute of Medicine on dietary reference values for vitamin intake; replacing the previously published Recommended Dietary Allowance).
https://ods.od.nih.gov/factsheets/Folate-HealthProfessional/ (Fact sheet on folate maintained and regularly updated by the Office of Dietary Supplements, National Institutes of Health).
Lonn E, Yusuf S, Arnold MJ, Sheridan P, Pogue J, Micks M, McQueen MJ, et al; Heart Outcomes Prevention Evaluation (HOPE) 2 Investigators. Homocysteine lowering with folic acid and B vitamins in vascular disease. N Engl J Med 2006; 354: 1567-77. (Among 5522 adults with vascular disease or diabetes treated with folate [2.4 mg daily] with vitamins B6 and B12 vs placebo for an average of 5 years, active vitamin supplementation did not reduce overall, cardiovascular or cancer death rates; no mention of ALT elevations or hepatotoxicity). 16531613
Cole BF, Baron JA, Sandler RS, Haile RW, Ahnen DJ, Bresalier RS, McKeown-Eyssen G, et al.; Polyp Prevention Study Group. Folic acid for the prevention of colorectal adenomas: a randomized clinical trial. JAMA 2007; 297: 2351-9. (Among 1021 adult patients with colorectal adenomas treated with folic acid [1 mg daily] vs placebo with or without aspirin for up to 8 years, the rate of recurrent adenomas was not reduced with either folate or aspirin; no mention of ALT elevations or hepatotoxicity). 17551129
Albert CM, Cook NR, Gaziano JM, Zaharris E, MacFadyen J, Danielson E, Buring JE, et al. Effect of folic acid and B vitamins on risk of cardiovascular events and total mortality among women at high risk for cardiovascular disease: a randomized trial. JAMA 2008; 299: 2027-36. (Among 5442 adult women treated with folic acid and vitamins B6 and B12 vs placebo for an average of 7.3 years, vitamin supplementation had no effect on overall cardiovascular disease event rates [14.9% vs 14.3%]; no mention of ALT elevations or hepatotoxicity). 18460663
Ebbing M, Bønaa KH, Nygård O, Arnesen E, Ueland PM, Nordrehaug JE, Rasmussen K, et al. Cancer incidence and mortality after treatment with folic acid and vitamin B12. JAMA 2009; 302: 2119-26. (In a combined analysis of two studies with extended follow up in 6837 Norwegian adults with ischemic heart disease who were treated with B vitamins and folate [0.8 mg daily] vs placebo, cancer rates [particularly lung cancer] were slightly higher in the supplemented group [10% vs 8.4%]; no mention of adverse events, ALT elevations or hepatotoxicity). 19920236
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2020949552) (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to folate, niacin or the water soluble vitamins).
Andreeva VA, Touvier M, Kesse-Guyot E, Julia C, Galan P, Hercberg S. B vitamin and/or ω-3 fatty acid supplementation and cancer: ancillary findings from the supplementation with folate, vitamins B6 and B12, and/or omega-3 fatty acids (SU.FOL.OM3) randomized trial. Arch Intern Med 2012; 172: 540-7. (Among 2511 adults treated with combination of B vitamins and folate versus placebo for average of 4.7 years, vitamin supplementation had no effect on cancer incidence or mortality; no mention of adverse events, ALT elevations or hepatotoxicity). 22331983
Vollset SE, Clarke R, Lewington S, Ebbing M, Halsey J, Lonn E, Armitage J, et al.; B-Vitamin Treatment Trialists' Collaboration. Effects of folic acid supplementation on overall and site-specific cancer incidence during the randomised trials: meta-analyses of data on 50,000 individuals. Lancet 2013; 381 (9871): 1029-36. (In a metaanalysis of 13 controlled trials of folate supplementation vs placebo in 46,969 adult patients followed for an average of 5.2 years, folate had no effect on overall cancer incidence or on site specific cancer rates [including liver]; no mention of ALT elevations or hepatotoxicity). 23352552
Shea B, Swinden MV, Ghogomu ET, Ortiz Z, Katchamart W, Rader T, Bombardier C, et al. Folic acid and folinic acid for reducing side effects in patients receiving methotrexate for rheumatoid arthritis. J Rheumatol 2014; 41: 1049-60. (Metaanalysis of 6 controlled trials of folate [folinic or folic acid] vs placebo supplementation during methotrexate therapy of rheumatoid arthritis found that folate decreased the rates of ALT elevations [5.6% vs 20.8%] and drug discontinuations without changing evidence for efficacy of methotrexate). 24737913
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 were attributed to niacin, but none were attributed to any other vitamin including folic acid). 25754159
Biesalski HK, Tinz J. Multivitamin/mineral supplements: Rationale and safety - A systematic review. Nutrition 2017; 33: 76-82. (Review of safety of multivitamins stresses the lack of information on adverse events in trials of vitamin supplementation, but concludes that multivitamins are safe at physiological doses in the short and long term). 27553772
Field MS, Stover PJ. Safety of folic acid. Ann N Y Acad Sci. 2017 Nov 20. [Epub ahead of print] (Review of long term safety of folate supplementation summaries two government-supported expert panel reviews that concluded that there is no evidence for adverse effects of folic acid fortification of food). 29155442

## OTHER REFERENCE LINKS

1. Recent References on Folic Acid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Folic%20Acid/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Folic Acid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Folic%20Acid)